# Tetracyclines

## OVERVIEW

The tetracyclines are broad-spectrum, bacteriostatic antibiotics that are active against many pathogens including gram positive and gram negative bacteria, spirochetes, chlamydia, leptospira, mycoplasma and rickettsia. They are widely used in medical practice, but currently have restricted usefulness. Tetracyclines act by binding to bacterial ribosomes inhibiting protein synthesis. Bacterial resistance is common and is usually caused by plasmid encoded efflux pumps (which actively export the drug from the cell) and ribosomal protection proteins.

At least eight different tetracyclines are currently available in the United States: tetracycline, doxycycline, minocycline, tigecycline, sarecycline, omadacycline, eravacycline, and demeclocycline. Several other tetracyclines have been used in the past in the United States or Europe, but have been withdrawn (chlortetracycline, rolitetracycline, oxytetracycline). While tetracyclines are capable of causing a distinctive form of acute fatty liver disease when given intravenously in high doses, liver injury from oral forms of tetracyclines vary greatly in frequency and clinical features. Minocycline is the most commonly implicated tetracycline in causing liver injury and generally ranks within the 10 most common causes of drug induced liver injury in the United States. Minocycline hepatotoxicity generally presents with a long latency, hepatocellular enzyme elevations, prominent autoimmune features, apparent response to corticosteroid therapy and relatively benign course. Doxycycline, in contrast, usually presents with a short latency (within 1 to 60 days), a variable pattern of enzyme elevations (cholestatic, mixed, or hepatocellular), mild immunoallergic or autoimmune features, and sometimes a prolonged, but ultimately benign course. The other tetracyclines have had limited clinical use and are generally suspected but unproven potential causes of liver injury.

1. Demeclocycline

2. Doxycycline

3. Eravacycline

4. Minocycline

5. Omadacycline

6. Sarecycline

7. Tetracycline

8. Tigecycline

## ANNOTATED BIBLIOGRAPHY

References updated: 15 June 2026

Abbreviations used: ULN, upper limit of normal; iv, intravenous; ANA, antinuclear antibody; HLA, human leucocyte antigen.

Zimmerman HJ. Tetracyclines. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. p. 599-602. (Expert review of tetracycline and liver injury published in 1999; the tetracyclines cause two forms of drug induced liver injury, microvesicular fat and liver failure occurring after 4-10 days with high doses of parenteral tetracyclines and an idiosyncratic liver injury that occurs with the oral agents, doxycycline causing a cholestatic and minocycline a hepatocellular injury which may be associated with autoimmune features).
Moseley RH. Tetracyclines. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 468. (Expert review of tetracycline induced liver injury mentions that the hepatotoxicity of intravenous tetracycline is of historic interest only as it is no longer given parenterally; both doxycycline and minocycline have been associated with idiosyncratic liver injury).
MacDougall C. Protein synthesis inhibitors and miscellaneous antibacterial agents. In, Brunton LL, Hilal-Dandan R, Knollmann BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1049-65. (Textbook of pharmacology and therapeutics).
Schultz JC, Adamson JS Jr, Workman WW, Norman TD. Fatal liver disease after intravenous administration of tetracycline in high dosage. N Engl J Med 1963; 269: 999-1004. (Initial dramatic report of acute fatty liver due to intravenous [iv] tetracycline; a rapidly fatal multisystem disease appeared in 6 pregnant women in their last trimester or early postpartum period after 3 to 5 days of relatively high doses of iv tetracycline; all developed jaundice [bilirubin 4.9-12.5 mg/dL] with mild AST [72-170 U/L] and Alk P [9-17 King Armstrong U/L] elevations, prolongation of protime, acidosis, and renal dysfunction. Autopsy showed foamy hepatocytes, fat by oil red O stain and minimal hepatocyte necrosis; this syndrome likely due to lactic acidosis, steatosis, and hepatic dysfunction [LASH]). 14059734
Tetracyclines and the liver in pregnancy. Lancet 1966; 1: 357-8. (Editorial on the history of acute fatty liver of pregnancy, first described by Sheehan in 1940 and later linked to high dose iv tetracycline in pregnancy, but also in nonpregnant women and in men). 4159865
Peters RL, Edmondson HA, Mikkelsen WP, Tatter D. Tetracycline-induced fatty liver in nonpregnant patients. A report of six cases. Am J Surg 1967; 113: 622-32. (Classical description of clinical and histologic features of tetracycline induced acute fatty liver in nonpregnant patients; 6 nonpregnant women, ages 18-62, given iv tetracycline for 3-13 days [9-26 g] presenting with jaundice and lethargy; peak AST 52-960 U/L; bilirubin 2.7-7.4 mg/dL, often with complex and critical course, pancreatitis and renal failure, acidosis; fatty liver on autopsy). 6021433
Combes B, Whalley PJ, Adams RH. Tetracycline and the liver. Prog Liver Dis 1972; 4: 589-96. (Review of hepatotoxicity of tetracycline, including studies of pathogenesis). 4569011
Adams LE, Hess EV. Drug-related lupus. Incidence, mechanisms and clinical implications. Drug Saf 1991; 6: 431-49. (Review of drug related lupus-like syndrome, linked to more than 60 agents including isoniazid, hydralazine, chlorpromazine, methyldopa, and procainamide. Usually presents with arthralgias and fever and ANA positivity, usually occurring with long term use of the medication). 1793523
Carson JL, Strom BL, Duff A, et al. Acute liver disease associated with erythromycins, sulfonamides, and tetracyclines. Ann Intern Med 1993; 119 (7 Pt 1): 576-83. (Case control study using Medicaid billing results between 1980-87 found 107 cases of hospitalization for unexplained hepatitis, odds ratios for erythromycin 5.2; sulfonamides 11.4; tetracyclines 5.2; total of 5 cases exposed to tetracycline, doxycycline or minocycline). 8363168
Hunt CM, Washington K. Tetracycline-induced bile duct paucity and prolonged cholestasis. Gastroenterology 1994; 107: 1844-7. (Two cases of severe and prolonged cholestatic hepatitis with bile duct paucity after oral tetracyclines; 37 year old woman developed jaundice 2 days after 3 day course of doxycycline with prolonged cholestasis [peak bilirubin 30 mg/dL], but ultimate recovery; 63 year old woman developed jaundice 6 weeks after a 2 week course of tetracycline [bilirubin 11.8 mg/dL, ALT 245 U/L], with prolonged jaundice [peak bilirubin 29.5 mg/dL) and persistence of enzyme elevations for >3 years [Alk P 631 U/L, ALT 97 U/L]). 7958700
Friis H, Andreasen PB. Drug-induced hepatic injury: an analysis of 1100 cases reported to the Danish Committee on Adverse Drug Reactions between 1978 and 1987. J Intern Med 1992; 232: 133-8. (Adverse drug reaction reports between 1978 and 1987 in Denmark; no tetracycline is mentioned as a cause). 1506809
Pillans PI. Drug associated hepatic reactions in New Zealand: 21 years’ experience. N Z Med J 1996; 109: 315-9. (Adverse drug reaction reports identified 943 liver injuries over 21 years in New Zealand; triacetyloleandomycin accounted for 21 cases [2.1%] and minocycline for at least 4). 8816722
Knowles SR, Shapiro L, Shear NH. Serious adverse reactions induced by minocycline. Report of 13 patients and review of the literature. Arch Dermatol 1996; 132: 934-9. (15 cases with adverse reactions to minocycline; one with Stevens-Johnson syndrome and acute liver failure arising within 29 days of starting minocycline, necessitating liver transplantation). 8712844
Björnsson E, Lindberg J, Olsson R. Liver reactions to oral low-dose tetracyclines. Scand J Gastroenterol 1997; 32: 390-5. Review. PMID: 9140164 (32 year old man developed abdominal pain, dark urine and rash within 24 hours of starting doxycycline which he had received in the past [bilirubin 4.3- 8.1 mg/dL, ALT 3.5 times ULN, Alk P 1.1 times ULN], resolving within 3 months of stopping; thorough review of all published and SADRAC reported cases of oral tetracycline associated liver injury found 15 cases, only 6 rated as likely, none with tetracycline, 5 doxycycline, 1 lymecycline).
Shapiro LE, Knowles SR, Shear NH. Comparative safety of tetracycline, minocycline, and doxycycline. Arch Dermatol 1997; 133: 1224-30. (Review of toxicity of tetracyclines from literature and a Canadian database; minocycline had the highest rates of adverse events, but all were relatively safe: no lupus-like syndrome associated with doxycycline or tetracycline). 9382560
Elkayam O, Yaron M, Caspi D. Minocycline-induced autoimmune syndromes: an overview. Semin Arthritis Rheum 1999; 28: 392-7. (Systematic review of literature on autoimmune syndromes from minocycline, 4 patterns: serum sickness, lupus-like syndrome, autoimmune hepatitis, and vasculitis; usually presenting after 1-20 years, ANA common but so is pANCA, features may overlap, hepatitis most common: 66 cases reported). 10406406
Goldstein NS, Bayati N, Silverman AL, Gordon SC. Minocycline as a cause of drug-induced autoimmune hepatitis. Report of four cases and comparison with autoimmune hepatitis. Am J Clin Pathol 2000; 114: 591-8. (Four cases of minocycline hepatitis and comparison to 10 spontaneous autoimmune hepatitis cases showed no distinguishing features except resolution with stopping drug; 16-52 year old women developed liver injury 4 months to 12 years after starting minocycline [bilirubin 0.4, 1.2, 6.5 and 7.3 mg/dL, ALT 137, 343, 700, and 1288 U/L, Alk P 49, 83, 138 and 253 U/L, all ANA positive], histology showed fibrosis in 2, all responded to prednisone with resolution persisting after stopping corticosteroids). 11026106
Goh KP. Management of hyponatremia. Am Fam Physician 2004; 69: 2387-94. (Review of the causes, diagnosis and management of hyponatremia and inappropriate antidiuretic hormone syndrome, with discussion of use of demeclocycline). 15168958
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, none of which were attributed to minocycline, doxycycline, or tetracycline). 15390328
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-1101. (Among 103 cases of fulminant drug induced liver injury reported to a Swedish registry between 1966 and 2002, one case was attributed to doxycycline, but no other tetracycline mentioned). 16165719
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, Garcia-Ruiz E, Garcia-Munoz B, et al. Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish Registry over a 10-year period. Gastroenterology 2005; 129: 512-21. (Reports to a Spanish network found 461 cases of drug induced liver disease; no tetracycline was listed among the top 20 agents implicated [at least 5 cases]). 16083708
Rubinstein E, Vaughan D. Tigecycline: a novel glycylcycline. Drugs 2005; 65: 1317-36. (Review article on tigecycline reporting low rates of ALT and AST elevations [<2%] in phase III randomized controlled trials). 15977966
Sacchidanand S, Penn RL, Embil JM, Campos ME, Curcio D, Ellis-Grosse E, Loh E, Rose G. Efficacy and safety of tigecycline monotherapy compared with vancomycin plus aztreonam in patients with complicated skin and skin structure infections: Results from a phase 3, randomized, double-blind trial. Int J Infect Dis 2005; 9: 251-61. (Randomized controlled trial of tigecycline [n=292] vs vancomycin and aztreonam [n= 281] for up to 14 days; ALT and AST elevations occurred in 1-2% of tigecycline vs 5-6% of comparator recipients; no case of clinically apparent liver disease). 16099700
Heaton PC, Fenwick SR, Brewer DE. Association between tetracycline or doxycycline and hepatotoxicity: a population based case-control study. J Clin Pharm Ther 2007; 32: 483-7. (Analysis of 2 years of Medicaid claims in California found 3377 cases of “hepatotoxicity”; 20 had received tetracycline <45 days before onset; only 4 controls had: adjusted odds ratio 3.7; not elevated for doxycycline; this despite safety record of oral tetracyclines and known hepatotoxicity of doxycycline). 17875115
Tanaseanu C, Bergallo C, Teglia O, Jasovich A, Oliva ME, Dukart G, Dartois N, Cooper CA, Gandjini H, Mallick R; 308 Study Group; 313 Study Group. Integrated results of 2 phase 3 studies comparing tigecycline and levofloxacin in community-acquired pneumonia. Diagn Microbiol Infect Dis 2008; 61: 329-38. (Combined results of two clinical trials comparing tigecycline to levofloxacin in 846 patients with pneumonia found similar efficacy [74-86%]; nausea and vomiting were more common with tigecycline; ALT elevations occurred in 2.6% of tigecycline vs 6.4% of levofloxacin treated patients; no mention of hepatitis or jaundice). 18508226
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, minocycline accounted for 3 cases, doxycycline for 3 cases and tetracycline was listed as a secondary possible cause for one). 18955056
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database containing 9036 hepatic adverse drug reactions in children includes 117 cases attributed to minocycline, but no other tetracycline listed in the top 40 causes). 21039766
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; none were due to tetracyclines). 20648003
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver including 2 due to doxycycline but none to minocycline or other tetracyclines). 20949552
Leitner JM, Graninger W, Thalhammer F. Hepatotoxicity of antibacterials: Pathomechanisms and clinical. Infection 2010; 38: 3-11. (Review of hepatotoxicity of antibiotics; mentions that hepatotoxicity from oral tetracycline is rare ~1.5 cases per million prescriptions, whereas minocycline has been associated with either an immediate reaction with eosinophilia, dermatitis, and enzyme elevations or a delayed autoimmune hepatitis-like syndrome). 20107858
Kadoyama K, Sakaeda T, Tamon A, Okuno Y. Adverse event profile of tigecycline: data mining of the public version of the U.S. Food and Drug Administration adverse event reporting system. Biol Pharm Bull. 2012; 35: 967-70. (Analysis of adverse event reports on tigecycline compared to other agents, suggested increased rates of nausea, vomiting, pancreatitis, liver failure, and ALT and Alk P elevations). 22687540
Noel GJ, Draper MP, Hait H, Tanaka SK, Arbeit RD. A randomized, evaluator-blind, phase 2 study comparing the safety and efficacy of omadacycline to those of linezolid for treatment of complicated skin and skin structure infections. Antimicrob Agents Chemother 2012; 56: 5650-4. (Among 219 adults with complicated skin and skin structure infections treated with omadacycline vs linezolid, clinical response rates were similar [97% vs 93%] as were adverse event rates, ALT elevations occurring in 3% of both groups). 22908151
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to doxycycline or other tetracyclines). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, 37 of which were attributed to an antibiotic, but none to a tetracycline). 24552865
Douros A, Bronder E, Andersohn F, Klimpel A, Thomae M, Sarganas G, Kreutz R, et al. Drug-induced liver injury: results from the hospital-based Berlin Case-Control Surveillance Study. Br J Clin Pharmacol 2015; 79: 988-99. (Among 76 inpatients with hepatitis of uniknown cause enrolled in a prospective case-cohort surveillance study between 2002 and 2011, one was attributed to doxycycline, but no other tetracycline was implicated). 25444550
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 323 [36%] were attributed to antibiotics including 28 [3%] to minocycline and 4 [0.4%] to doxycycline). 25754159
Zhanel GG, Cheung D, Adam H, Zelenitsky S, Golden A, Schweizer F, Gorityala B, et al. Review of eravacycline, a novel fluorocycline antibacterial agent. Drugs 2016; 76: 567-88. (Review of the structure, antibacterial spectrum of activity, pharmacology, clinical efficacy, and safety of eravacycline; mentions that the most common adverse event is nausea and vomiting, but that other event rates are similar to those in comparator arm subjects; no discussion of ALT elevations or hepatotoxicity). 26863149
Solomkin J, Evans D, Slepavicius A, Lee P, Marsh A, Tsai L, Sutcliffe JA, et al. Assessing the efficacy and safety of eravacycline vs ertapenem in complicated intra-abdominal infections in the investigating gram-negative infections treated with eravacycline (IGNITE 1) trial: a randomized clinical trial. JAMA Surg 2017; 152: 224-32. (Among 541 patients with complicated intraabdominal infections treated with eravacycline [1 mg/kg every 12 hours] or ertapenem [1 gm every 24 hours] for 4-14 days, rates of clinical cure were similar [87% vs 88%] while adverse events were more frequent with eravacycline [42% vs 28%], although severe adverse event rates were similar [6.0% vs 5.6%]; no mention of ALT elevations or hepatotoxicity). 27851857
Urban TJ, Nicoletti P, Chalasani N, Serrano J, Stolz A, Daly AK, Aithal GP, et al; Drug-Induced Liver Injury Network (DILIN); Pharmacogenetics of Drug-Induced Liver Injury group (DILIGEN); International Serious Adverse Events Consortium (iSAEC). Minocycline hepatotoxicity: clinical characterization and identification of HLA-B*35:02 as a risk factor. J Hepatol 2017; 67: 137-44. (The uncommon human leukocyte antigen [HLA] allele B*35:02 was found in 4 of 25 [16%] of patients with minocycline hepatotoxicity vs 0.6% in a population control group; those with and without this allele did not differ in clinical features or outcomes). 28323125
Leyden JJ, Sniukiene V, Berk DR, Kaoukhov A. Efficacy and safety of sarecycline, a novel, once-daily, narrow spectrum antibiotic for the treatment of moderate to severe facial acne vulgaris: results of a phase 2, dose-ranging study. J Drugs Dermatol 2018; 17: 333-8. (Among 285 patients, ages 12 to 45 years, with severe facial acne vulgaris treated with 3 doses of sarecycline or placebo once daily for 12 weeks, inflammatory lesions were improved with higher doses of sarecycline vs placebo while adverse event rates were comparable and there were no serious adverse events; no mention of ALT elevations or hepatotoxicity). 29537451
Markham A, Keam SJ. Omadacycline: first global approval. Drugs 2018; 78: 1931-7. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of omadacycline shortly after its first approval for use in the US; mentions that ALT or AST elevations arose in 3-4% of patients treated with omadacycline but that similar rates were reported in patients on comparator antibiotic regimens). 30471003
Deeks ED. Sarecycline: first global approval. Drugs. 2019; 79: 325-9. (Review of the mechanism of action, pharmacology, clinical efficacy, and safety of sarecycline from clinical trials on which its FDA approval was based; mentions that adverse events were uncommon but included nausea, vomiting, abdominal pain, sunburn, vulvovaginal candidiasis and mycotic infections; no mention of ALT elevations or hepatotoxicity). 30659422
Pariser DM, Green LJ, Lain EL, Schmitz C, Chinigo AS, McNamee B, Berk DR. Safety and tolerability of sarecycline for the treatment of acne vulgaris: results from a phase III, multicenter, open-label study and a phase I phototoxicity study. J Clin Aesthet Dermatol. 2019;12:E53-E62. (Among 483 patients with moderate-to-severe acne treated with sarecycline an open label extension study for up to 40 weeks, adverse events arose in 39% of patients but only 4 were considered serious none of which were considered liver-related and none considered drug-related; ALT elevations arose in 3 patients [0.6%] but all were transient and less than 3 times ULN). 32038757
Varma S, Nathanson J, Dowlatshahi M, Del Portillo A, Ramirez I, Garcia-Carrasquillo R. Doxycycline-induced cholestatic liver injury. Clin J Gastroenterol. 2021;14:1503-1510.. (43 year old woman developed fatigue, fever, and nausea beginning 3 days after starting doxycycline and, despite stopping the drug, was followed by dark urine and jaundice [bilirubin 12.5 mg/dL, ALT 83 U/L, Alk P 339 U/L], jaundice clearing in 1-2 months and all tests normal at 5 months). 34228348
Wei C, Liu Y, Jiang A, Wu B. A pharmacovigilance study of the association between tetracyclines and hepatotoxicity based on Food and Drug Administration adverse event reporting system data. Int J Clin Pharm. 2022;44:709-716. [] (Analysis of tetracyclines in the FDA’s Adverse Event Reporting System [FAERS] over a 16 year period, identified 1435 cases of liver injury, the most being with minocycline [n=547], doxycycline [545], tigecycline [288], and tetracycline [41] with few to omadacycline [4], oxytetracycline [3], eravacycline [2], sarecycline [2], and demeclocycline [1]; no clinical details provided). 35364753
Weber S, Gerbes AL. Relapse and need for extended immunosuppression: novel features of drug-induced autoimmune hepatitis. Digestion. 2023;104(3):243-248. (Comparison of patients with autoimmune hepatitis [n=19] vs autoimmune-like drug induced liver injury [n=11, 1 due to minocycline] found differences only in the need for long-term immunosuppression [27% vs 13%]). 36603570
García-Cortés M, Ortega-Alonso A, Matilla-Cabello G, Medina-Cáliz I, Castiella A, Conde I, Bonilla-Toyos E, et al. Clinical presentation, causative drugs and outcome of patients with autoimmune features in two prospective DILI registries. Liver Int. 2023;43:1749-1760. (Among 1426 patients enrolled in the Spanish and Latin American Drug Induced Liver Injury Registries, 33 had autoimmune-like liver injury, which were 58% females, 84% hepatocellular, typically with a long latency, 91% with ANA, 34% SMA, 12% severe and 3% fatal; 8 due to statins, 5 nitrofurantoin, 4 minocycline, only 1 an herbal product). 37269163
Nikolajevic N, Nikolajevic M, Pantic I, Korica B, Kotseva M, Alempijevic T, Jevtic D, et al. Drug-induced liver injury due to doxycycline: a case report and review of literature. Cureus. 2024;16:e59687. (28 year old man with Lyme disease developed nausea 5 days after starting doxycycline [100 mg twice daily] with bilirubin 0.7 mg/dL, ALT 758 U/L, Alk P normal, INR 1.1 and improvement on stopping doxycycline and switching to amoxicillin, with normal liver tests one month later). 38836151
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952.. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be due to medications including doxycycline at an estimate rate of 1 per 3,700 persons per year of exposure). 38913369
Zhang Y, Wang J, Tan Y, Wu J. Acute liver failure caused by high dose tigecycline: a case report. Int J Clin Pharmacol Ther. 2024;62:339-344. (76 year old woman with subarachnoid hemorrhage developed ventilator induced pneumonia and was treated with high dose intravenous tigecycline [100 mg every 12 hours] for 15 days when she was found to have jaundice [bilirubin 9.1 mg/dL, ALT 15 U/L, Alk P 346 U/L], and had progressive hepatic failure [bilirubin rising above 30 mg/dL, INR 5.7] despite stopping tigecycline, dying of multiorgan failure 10 days later). 38606856
Turan Gökçe D, Arı D, Aydın O, Turhan N, Altunsoy A, Ökten RS, Akdoğan Kayhan M. Tigecycline-associated hepatic steatosis after liver transplant: a case report. Exp Clin Transplant. 2024;22:318-321. (Two women, ages 61 and 53 years, developed infections after liver transplantation and received tigecycline [100 mg once, then 50 mg twice daily iv for 6 and 16 days] and developed rising ALT and bilirubin levels, with liver biopsies a few days later showing marked macrovesicular fat, Mallory bodies, and canalicular cholestasis; the liver injury resolving after discontinuation). 38742325
Drugs for acne. Med Lett Drugs Ther. 2024;66(1695):17-20.. (Concise review of the mechanism of action, efficacy, safety, and costs of drugs for acne mentions that oral tetracyclines well tolerated and can be used long-term; no mention of ALT elevations or hepatotoxicity). 38294764
Bessone F, Bjornsson ES. Autoimmune-like hepatitis induced by drugs: still many unanswered questions. World J Hepatol. 2025;17:110946. (Review of autoimmune-like drug induced liver injury and features that distinguish it from spontaneous, idiopathic autoimmune hepatitis, the major features being lack or minimal fibrosis and lack of relapse after resolution with or without corticosteroid therapy in drug-induced liver injury with autoimmune features that is common with chronic minocycline therapy in which relapse after corticosteroid-induced remission is very rare, but has been reported). 41368109
Chen VL, Rockey DC, Bjornsson ES, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network Investigators. Incidence of idiosyncratic drug-induced liver Injury caused by prescription drugs. Drug Saf. 2025;48:151-160.. (Analysis of 1284 cases of drug-induced liver injury enrolled in a U.S. prospective study, identified 6 cases [0.5%] attributed to doxycycline occurring at an estimated rate of 1 per 50,000 persons treated; and identified 44 cases [3.4%] attributed to minocycline being the 6th most commonly implicated drug and occurring at an estimated rate of 1 per 1,100 persons treated). 39317916
Reinhart JM. Drug-induced liver injury. Vet Clin North Am Small Anim Pract. 2025;55:717-730. (Extensive review of drug-induced liver injury in veterinary animals mentions that 39% of dogs and 19% of cats develop ALT elevations on doxycycline therapy but that clinically apparent injury must be rare). 40280782
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102. (Among 468 cases of idiosyncratic drug induced liver injury enrolled in a prospective Latin American database, 4 [0.9%] were attributed to minocycline, 1 [0.2%] each to doxycycline and tetracycline but none to eravacycline, omadacycline, sarecycline, or tigecycline). 38992407

## OTHER REFERENCE LINKS

1. Recent References on Tetracyclines: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=tetracycline/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Tetracyclines: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=tetracycline)